# Omeprazole

## OVERVIEW

### Introduction

Omeprazole and esomeprazole are proton pump inhibitors (PPIs) and potent inhibitor of gastric acidity which are widely used in the therapy of gastroesophageal reflux and peptic ulcer disease. Omeprazole and esomeprazole therapy are both associated with a low rate of transient and asymptomatic serum aminotransferase elevations and are rare causes of clinically apparent liver injury.

### Background

Omeprazole (oh mep' ra zole), like other PPIs, inhibits gastric acid production by binding to and inactivating the H+/K+-ATPase of gastric parietal cells, causing inhibition of the proton pump that transports H+ into the gastric lumen, the common final step in gastric acid production. Omeprazole is a prodrug and is converted to the active form (sulfenic acid) in the acidic secretory canaliculi of parietal cells. Because the inhibition is irreversible, acid secretion is suppressed for 24 to 48 hours, until new proton pump molecules have been synthesized and transported to the cell membrane. Omeprazole was the first PPI approved for use in the United States (1989), initially only for the indication of severe peptic ulcer disease and Zollinger-Ellison syndrome. Subsequently, the indications for its use have broadened to routine peptic ulcer disease, gastroesophageal reflux disease and prevention of stress ulcers.

Esomeprazole (es" oh mep' ra zole) is the S-isomer of omeprazole and exhibits delayed clearance and thus higher potency on a molar basis than omeprazole, which is a racemic mixture of both S- and R-isomers. The pharmacokinetics, mechanism of action and clinical efficacy of esomeprazole is quite similar to that of omeprazole. Esomeprazole was approved for use in the United States in 2001 with similar indications as omeprazole includig peptic ulcer disease, gastroesophageal reflux disease and prevention of stress ulcers.

Omeprazole and esomeprazole are two of the most widely used medications in clinical practice with more than 20 million prescriptions filled yearly in the United States alone. Omeprazole is available in multiple forms including 10, 20 and 40 mg standard and delayed release capsules and powder for oral suspension in generic forms and under the brand name of Prilosec. The typical dose of omeprazole is 20 mg once daily with twice daily doses for more severe cases of gastrointestinal reflux and peptic ulcer disease, and doses of up to 120 mg daily for Zollinger-Ellison syndrome. A 10 to 14 day course of omeprazole in combination with antibiotics is effective and recommended for the eradication of H. Pylori infection.

Esomeprazole is also available in multiple forms and typically used in 20 mg delayed release capsules generically and under the brand name Nexium. On a molar basis, esomeprazole is more potent than omeprazole and the recommended dose in adults is 20 mg once daily, with twice daily doses for more severe cases of gastrointestinal reflux and peptic ulcer disease, and doses of up to 60 mg daily for Zollinger-Ellison syndrome. Combinations of esomeprazole with antibiotics for 10 to 14 days are effective and recommended for eradication of H. pylori infection. Both omeprazole and esomeprazole are very well tolerated and both are now available without prescription in multiple over-the-counter forms. Side effects of omeprazole and esomeprazole are uncommon and usually mild; they include diarrhea, nausea, vomiting, abdominal discomfort, flatulence, skin rash, headaches and dizziness. Severe side effects are rare but can include hypersensitivity reactions. Long-term use of rabeprazole may be associated with bone fractures, acute interstitial nephritis, lupus erythematosus, vitamin B12 deficiency and hypomagnesemia.

### Hepatotoxicity

Despite their wide use, omeprazole and esomeprazole have only rarely been associated with hepatic injury. In large scale, long term trials , serum ALT elevations occurred in less than 1% of patients and at rates similar to those that occurred with placebo or comparator drugs. A small number of cases of clinically apparent liver disease due to omeprazole or esomeprazole have been published, the frequency of these cases probably being less than 1:100,000 users. A somewhat characteristic clinical phenotype has been described, with most cases arising during the first 1 to 4 weeks of therapy and being marked by an acute hepatocellular pattern of injury, with rapid recovery upon withdrawal. Rash, fever and eosinophilia were rare, as is autoantibody formation. Liver biopsy typically shows prominent centrolobular necrosis, suggestive of an acute, toxic hepatic injury (acute hepatic necrosis); however, recurrence upon rechallenge has been documented in several cases. In some instances, other organ involvement is prominent including rhabdomyolysis, lactic acidosis, renal insufficiency or Stevens Johnson syndrome. In large case series of drug induced liver injury, omeprazole and esomeprazole have accounted for few instances of symptomatic acute liver injury and rare instances of acute liver failure.

Likelihood score: B (rare but likely cause of clinically apparent liver injury).

### Mechanism of Injury

The acute onset and rapid recurrence of hepatic injury with omeprazole and esomeprazole suggests a hypersensitivity reaction, but may merely reflect altered metabolism or acute toxicity of a metabolic byproduct. The usual clinical phenotype is acute hepatic necrosis. Both omeprazole and esomeprazole are extensively metabolized by the hepatic P450 system and have multiple effects on the drug metabolizing system, including inhibition of CYP 2C19 and induction of CYP1A2, effects which may cause significant drug-drug interactions.

### Outcome and Management

The mild and asymptomatic elevations in serum aminotransferase that have been observed during omeprazole and esomeprazole therapy are usually transient and may resolve even without dose modification. Clinically apparent liver injury due to these agents, however, generally calls for prompt withdrawal. Severe injury due to omeprazole and esomeprazole is uncommon and most cases resolve promptly upon withdrawal. Cases of acute liver failure due to proton pump inhibitors have been described, but they are exceedingly rare. There is no information about cross sensitivity to liver injury among the various PPIs, but some degree of cross reactivity should be expected between omeprazole and its S-isomer, esomeprazole. Furthermore, the PPIs all share a benzimidazole structure, and caution should be used in attempting to reintroduce another PPI after clinically apparent hepatic injury due to an unrelated PPI.

Drug Class: Antiulcer Agents

Other Drugs in the Subclass, Proton Pump Inhibitors: Dexlansoprazole, Lansoprazole, Pantoprazole, Rabeprazole

## CASE REPORT

### Case 1. Acute liver failure attributed to omeprazole.

[Modified from: Jochem V, Kirkpatrick R, Greenson J, Brogan M, Sturgis T, Cook-Glenn C. Fulminant hepatic failure related to omeprazole. Am J Gastroenterol 1992; 87: 523-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/1553942)]

A 62 year old man with gastroesophageal reflux was treated with ranitidine (150 mg twice daily) for 10 days without improvement, whereupon he was switched to omeprazole (20 mg daily). Seventeen days later, he presented with a 4 day history of abdominal pain, nausea, vomiting, poor appetite and weakness. He had no previous history of liver disease, alcohol abuse or risk factors for viral hepatitis. He had a long history of hypertension and coronary artery disease and had been taking atenolol (100 mg daily), diltiazem (60 mg twice daily) and aspirin (325 mg daily) chronically. He denied taking acetaminophen. On examination, he was jaundiced and had mild asterixis without rash or peripheral manifestations of cirrhosis. Laboratory testing showed marked elevations in serum aminotransferase levels (ALT 9234 U/L, AST 2952 U/L), bilirubin (8.4 mg/dL) and prothrombin time (>100 seconds), with minimal increase in alkaline phosphatase levels (254 U/L). Serum lactate was elevated at 26.6 mmol/L and ammonia at 38 µmol/L. The peripheral white blood cell count was elevated (18,100 cells/µL) without eosinophilia and creatinine was 2.6 mg/dL. All liver tests had been normal when measured one month previously. Tests for hepatitis A, B and C were negative. He was managed in the intensive care unit but worsened overnight, becoming obtunded and then comatose. He was transferred to a tertiary medical center for possible liver transplantation, but rapidly developed respiratory and renal failure and died five days after his initial presentation. On autopsy, his liver showed massive centrolobular necrosis without fibrosis.

#### Key Points

Medication: | Omeprazole (20 mg daily)
Pattern: | Hepatocellular (R=100)
Severity: | 5+ (acute liver failure and death)
Latency: | 14 days to onset of symptoms
Recovery: | None
Other medications: | Atenolol, diltiazem and aspirin chronically, ranitidine for 10 days immediately before omeprazole was started

#### Comment

This patient developed fulminant hepatic failure and died within 3 weeks of starting omeprazole for gastroesophageal reflux. Spontaneous, idiopathic acute liver failure is very rare, but omeprazole use is common. For these reasons, a person taking omeprazole might develop acute liver failure by chance, unrelated to the medication. However, the onset of liver injury within a few weeks of starting omeprazole and the similarity in time to onset and enzyme pattern to other cases of omeprazole hepatotoxicity suggest that the proton pump inhibitor was the cause. Approximately 10% of causes of hepatocellular jaundice due to medications result in fatality, so that rare instances of proton pump inhibitor induced acute liver injury (which is typically hepatocellular) are likely to result in death. Acute liver failure with a short latency period (1 to 4 weeks) has also been reported with esomeprazole and with rabeprazole therapy.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Omeprazole – Generic, Prilosec®

Esomeprazole – Generic, Nexium®

DRUG CLASS

Antiulcer Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Omeprazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Omeprazole | 73590-58-6 | C17-H19-N3-O3-S | Omeprazole Chemical Structure
Esomeprazole | 119141-88-7 | C17-H19-N3-O3-S | Esomeprazole Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2019

Zimmerman HJ. Proton pump inhibitors. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 720-1. (Expert review of hepatotoxicity published in 1999 states that aminotransferase elevations occur in ~1% of PPI treated patients, but only 1 case of acute liver injury has been reported with omeprazole, none with the more recently released lansoprazole and pantoprazole).
Sharkey KA, McNaughton WK. Pharmacotherapy of gastric acidity, peptic ulcers, and gastroesophageal reflux disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 20181, pp. 409-420. (Textbook of pharmacology and therapeutics).
Gustavsson S, Adami HO, Lööf L, Nyberg A, Nyrén O. Rapid healing of duodenal ulcers with omeprazole: Double-blind dose comparative trial. Lancet 1983; 2: 124-5. (Controlled trial of two doses of omeprazole in 32 patients with duodenal ulcer reported a high rate of ALT elevations [32%] usually within the first 1-2 weeks, resolving rapidly on withdrawal; peak value 468 U/L). 6134979
Sharma BK, Santana IA, Walt RP, Pounder RE. Omeprazole and liver function tests. Lancet 1983; 2: 346. (Letter in response to Gustavsson [1983]; among 17 patients with duodenal ulcer treated with omeprazole, none had ALT or Alk P elevations). 6135864
Lööf L, Adami HO, Gustavsson S, Nyberg A, Nyrén O, Lundborg P. Omeprazole: no evidence for frequent hepatic reactions. Lancet 1984; 1: 1347-8. (Further follow up on the observation of Gustavsson [193], controlled trial of omeprazole in 60 volunteers monitored carefully for ALT elevations, found no association of drug with ALT elevations, being found in 1 of 30 on omeprazole and 2 of 30 on placebo; two patients with previous ALT elevations had no recurrence on rechallenge). 6145039
Lauritsen K, Rune SJ, Bytzer P, Kelbaek H, Jensen KG, Rask-Madsen J, Bendtsen F, et al. Effect of omeprazole and cimetidine on duodenal ulcer. A double-blind comparative trial. N Engl J Med 1985; 312: 958-61. (Controlled trial of omeprazole vs cimetidine for 4 weeks in 132 patients with duodenal ulcer disease found no major side effects; one patient on omeprazole had rise of Alk P to 756 U/L, resolving with stopping therapy and 4 had minor AST elevations at the end of therapy [36-54 U/L]). 3883182
Sölvell L. Safety aspects of omeprazole. Scand J Gastroenterol Suppl 1986; 118: 129-35. (Careful analysis of changes in serum ALT levels during omeprazole therapy in prospective studies found little evidence of changes compared to baseline or to placebo treatment; among more than 2500 recipients, only one report of increased ALT and none of hepatitis with jaundice). 3460168
Joelson S, Joelson IB, Lundborg P, Walan A, Wallander MA. Safety experience from long-term treatment with omeprazole. Digestion 1992; 51 (Suppl 1): 93-101. (Summary of adverse event profile in 2818 patients on long term omeprazole found low rate of side effects, similar in frequency to those on ranitidine or cimetidine; no mention of ALT elevations, hepatitis or jaundice). 1397750
Maton PN, Vinayek R, Frucht H, McArthur KA, Miller LS, Saeed ZA, Gardner JD, et al. Long-term efficacy and safety of omeprazole in patients with Zollinger-Ellison syndrome: a prospective study. Gastroenterology 1989; 97: 827-36. (40 patients with Zollinger-Ellison syndrome were treated for 6-51 months with omeprazole in doses of 20-120 mg/day; "No patient developed a side effect that could be attributed to omeprazole"). 2777040
Jochem V, Kirkpatrick R, Greenson J, Brogan M, Sturgis T, Cook-Glenn C. Fulminant hepatic failure related to omeprazole. Am J Gastroenterol 1992; 87: 523-5. (62 year old with reflux which did not improve with ranitidine therapy, developed pain, nausea and fatigue 17 days after starting omeprazole [bilirubin 8.6 mg/dL, ALT 9234 U/L, Alk P 254 U/L, protime >100 seconds], dying 5 days after admission and having massive centrolobular necrosis on autopsy: Case 1). 1553942
Sauvet P, Schouler L. [Omeprazole and liver functions]. Rev Med Interne 1992; 13: 359-63. French. (Review of the pharmacokinetics and hepatic metabolism of omeprazole and discussion of potential for hepatotoxicity). 1344831
Arnold R. Safety of proton pump inhibitors.an overview. Aliment Pharmacol Ther 1994; 8 Suppl 1: 65-70. (Side effects are uncommon and no more frequent than with cimetidine and ranitidine; "Omeprazole had no clinically relevant effects of laboratory values including...liver function"). 8180297
Klinkenberg-Knol EC, Festen HP, Jansen JB, Lamers CB, Nelis F, Snel P, Luckers A, et al. Long-term treatment with omeprazole for refractory reflux esophagitis: efficacy and safety. Ann Intern Med 1994; 121: 161-7. (91 patients with refractory esophagitis were treated with omeprazole [20-40 mg/day] for 3-5 years; generally well tolerated and no mention of ALT elevations or hepatotoxicity). 8017742
del Rio Fernandez M, Plagaro Cordero ME, de Frutos Arribas JF, Bellido Casado J, Velicia Llanes R. [Hepatic encephalopathy related to omeprazole]. Rev Esp Enferm Dig 1997; 89: 574-5. Spanish. (49 year old with diabetes, renal transplant, cirrhosis due to hepatitis C developed disorientation and worsening hepatic encephalopathy 6 days after starting omeprazole, recovering with stopping therapy, enemas and lactulose; authors suggest that omeprazole may have precipitated worsening of liver disease and encephalopathy). 9303628
d'Adamo G, Spinelli C, Forte F, Gangeri F. Omeprazole-induced acute interstitial nephritis. Ren Fail 1997; 19: 171-5. (Case of acute nephritis arising within a few weeks of starting omeprazole; no liver test abnormalities reported). 9044464
Navarro JF, Gallego E, Aviles J. Recurrent severe acute hepatitis and omeprazole. Ann Intern Med 1997; 127: 1135-6. (30 year old developed abdominal pain 9 days after starting omeprazole [ALT 1294 U/L], resolving in 4 weeks and arising again 1 week after restarting [ALT 762 U/L]; no mention of bilirubin or Alk P levels). 9412333
Christe C, Stoller R, Vogt N. Omeprazole-induced hepatotoxicity? A case report. Pharmacoepidemiol Drug Saf 1998; 7 Suppl 1: S41-4. (85 year old with congestive heart failure on long term omeprazole developed fatigue and worsening liver tests [bilirubin 2.0 mg/dL, ALT 263 rising to 1236 U/L, LDH 870 to 2100 U/L, Alk P 112 U/L], improving on stopping and with mild recurrence on restarting [ALT 500 U/L], patient dying 10 days later of acute myocardial infarction and heart failure). 15073958
Koury SI, Stone CK, La Charité DD. Omeprazole and the development of acute hepatitis. Eur J Emerg Med 1998; 5: 467-9. (39 year old found to have abnormal liver tests 4 weeks after starting omeprazole [bilirubin 0.6 mg/dL, ALT 262 U/L, Alk P 103 U/L], resolving within 2 weeks of stopping). 9919455
Koury SI, Stone CK, La Charité DD. Acute hepatitis induced by omeprazole. Am J Emerg Med 1998; 16: 550-1. (34 year old with chronic hepatitis C and peptic ulcer disease developed abdominal pain and nausea 2 weeks after starting omeprazole [bilirubin 0.3 mg/dL, AST 1059 U/L, Alk P 149 U/L]; rapid improvement on stopping). 9725985
Romero-Gómez M, Otero MA, Suárez-García E, García Díaz E, Fobelo MJ, Castro-Fernández M. Acute hepatitis related to omeprazole. Am J Gastroenterol 1999; 94: 1119-20. (34 year old developed jaundice 11 days after starting omeprazole [bilirubin 10.4 mg/dL, ALT 1100 U/L, Alk P 461 U/L], resolving in 6 months of stopping). 10201510
Reilly JP. Safety profile of the proton-pump inhibitors. Am J Health Syst Pharm 1999; 56 (23 Suppl 4): S11-7. (Review of side effects of proton pump inhibitors, including long term tolerance). 10597119
Martin RM, Dunn NR, Freemantle S, Shakir S. The rates of common adverse events reported during treatment with proton pump inhibitors used in general practice in England: cohort studies. Br J Clin Pharmacol 2000; 50: 366-72. (Prescription event monitoring of common side effects of omeprazole, lansoprazole and pantoprazole from the UK found low rates of diarrhea [0.18-0.39/1000 days], abdominal pain [0.17-.21], nausea [0.16-0.22] and headache [0.10-0.17]; no analysis of liver toxicities). 11012560
Johnson TJ, Hedge DD. Esomeprazole: a clinical review. Am J Health Syst Pharm 2002; 59: 1333-9. (Esomeprazole is the S-isomer of omeprazole and the two are similar in tolerability; no specific discussion of hepatotoxicity). 12132559
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to an H2 blocker or proton pump inhibitor). 15390328
de Abajo FJ, Montero D, Madurga M, García Rodríguez LA Acute and clinically relevant drug-induced liver injury: a population based case-control study. Br J Clin Pharmacol 2004; 58: 71-80. (Analysis of General Practice Research Database from UK on 1.6 million persons from 1994-2000 found 128 cases of drug induced liver injury [2.4/100,000 person years]; 3 cases were attributed to cimetidine for an odds ratio of 2.0 compared to controls [n=5000], which was not statistically significant). 15206996
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of DILI with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002: 103 cases identified as highly probable, probable or possible, one case attributed to ranitidine and one to omeprazole). 16165719
Capitain O, Lortholary A, Abadie-Lacourtoisie S. [Cytolytic hepatitis and esomeprazole during chemotherapy]. Presse Med 2005; 34: 1235-6. French. (41 year old woman on cyclic chemotherapy for breast cancer received a single dose of esomeprazole and developed abdominal pain and fatigue, and liver tests were abnormal 7 days later [bilirubin normal, ALT 13 times and Alk P 1.5 times ULN], resolving in 8 days). 16230965
El-Matary W, Dalzell M. Omeprazole-induced hepatitis. Pediatr Emerg Care 2005; 21: 529-30. (15 year old with Crohn disease and acute gastritis developed jaundice 5 days after starting omeprazole [bilirubin 3.2 mg/dL, ALT 218 U/L, Alk P 3018 U/L, INR 1.9], resolving rapidly, all except Alk P being normal within 6 days of stopping). 16096600
Youssef SS, Iskandar SB, Scruggs J, Roy TM. Acute pancreatitis associated with omeprazole. Int J Clin Pharmacol Ther 2005; 43: 558-61. (83 year old developed symptomatic pancreatitis 2 months after starting omeprazole [amylase 1,137 U/L, lipase 542 U/L], improving promptly on stopping and recurring within 2 days of restarting [amylase 233 U/L, lipase 648 U/L]; no liver test abnormalities mentioned). 16372517
Salgueiro E, Rubio T, Hidalgo A, Manso G. Safety profile of proton pump inhibitors according to the spontaneous reports of suspected adverse reactions. Int J Clin Pharmacol Ther 2006; 44: 548-56. (Analysis of reports to the Spanish Pharmacovigilance Database during 2004 found 58 reports of liver injury from PPIs including omeprazole [n=36], lansoprazole [7], pantoprazole [12], rabeprazole [2] and esomeprazole [1], correlating somewhat with relative number of prescriptions; 82% were taking other medications; most "evolved to recovery"). 17176621
Sánchez Garrido A. [Omeprazole-induced acute cholestatic hepatitis]. Gastroenterol Hepatol 2007; 30: 54. Spanish. (37 year old developed jaundice 4 days after starting omeprazole [bilirubin 14.2 mg/dL, ALT 852 U/L, Alk P 539 U/L], with resolution in 3 months). 17266883
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Population based survey of 126 cases of acute liver injury due to drugs between 1993-1999 in Spain; 8 were attributed to ranitidine alone [incidence 5.1/100,000 person years] and 5 to omeprazole alone [2.1/100,000]). 17539979
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 2 were attributed to ranitidine, none to cimetidine or omeprazole). 18955056
Domínguez-Leñero V, Barrera-Ledesma M, Romero-Alonso M, Garrido Martínez MT. [Stevens-Johnson syndrome and toxic hepatitis due to esomeprazole]. Farm Hosp 2009; 33: 118-9. Spanish. (66 year old with dyspepsia developed fever, diarrhea and severe rash 9 days after switching from pantoprazole to esomeprazole [40 mg/day], evolving to full fledged Stevens Johnson syndrome with hypotension, septic shock, and death from multiorgan [including hepatic] failure; few details given). 19480805
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (World wide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, there were no antiulcer medications in the top 40 causes). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, none were attributed to omeprazole or other antiulcer medications). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to omeprazole or other proton pump inhibitors). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to antiulcer medications, either H2 blockers or proton pump inhibitors). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 3 [0.3%] were attributed to a proton pump inhibitor, including one each for esomeprazole, omeprazole and lansoprazole). 25754159
van der Schaft J, van Schaik RH, van den Broek MP, Bruijnzeel-Koomen CA, de Bruin-Weller MS. Increased liver enzyme levels during azathioprine treatment: beware of concomitant use of proton pump inhibitors. Br J Dermatol 2015; 173: 1338-9. (Three patients with atopic dermatitis treated with azathioprine [150 mg daily] developed ALT elevations 2-5 weeks after starting pantoprazole or omeprazole [ALT 14 to 25 U/L before rising to 42 to 254 U/L after], resolving within 1-6 months after stopping the PPI despite continuation of azathioprine). 26139089
Thomas B, Mohamed M, Al Hail M, Awwad FA, Wahba RM, Hassan SB, Omar K, et al. A case of probable esomeprazole-induced transient liver injury in a pregnant woman with hyperemesis. Clin Pharmacol 2016; 8: 199-202. (22 year old woman in first trimester developed pain and nausea after starting metoclopramide and esomeprazole [40 mg twice daily] for hyperemesis gravidarum [bilirubin not provded, ALT 267 U/L, Alk P 69 U/L], resolving rapidly on switching to pantoprazole).28008288
Tsai CF, Chen MH, Wang YP, Chu CJ, Huang YH, Lin HC, Hou MC, Let al. Proton pump inhibitors increase risk for hepatic encephalopathy in patients With cirrhosis in a population study. Gastroenterology 2017; 152: 134-41. (Analysis of the Taiwan National Health Insurance database found a higher rate of PPI use among patients with cirrhosis who developed hepatic encephalopathy [38%: 445 of 1166] compared to a matched group with cirrhosis who did not [rate not provided]; the relative risk was raised for all agents except for rabeprazole). 27639806
Weersink RA, Bouma M, Burger DM, Drenth JPH, Froukje Harkes-Idzinga S, Hunfeld NGM, Metselaar HJ, et al. Safe use of proton pump inhibitors in patients with cirrhosis. Br J Clin Pharmacol 2018; 84: 1806-20. (Systematic review of 69 publications in the literature suggested plasma levels of many PPIs are several fold elevated cirrhosis, but less so for omeprazole and esomeprazole but only esomeprazole should be used in patients with Child Pugh Class C cirrhosis). 29688583

## OTHER REFERENCE LINKS

1. Recent References on Omeprazole and Esomeprazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Omeprazole/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Omeprazole and Esomeprazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Omeprazole)